# Thioridazine

## OVERVIEW

### Introduction

Thioridazine is a phenothiazine and antipsychotic agent that is no longer in common use. Thioridazine has been linked to rare instances of clinically apparent acute cholestatic liver injury.

### Background

Thioridazine is a piperazine phenothiazine derivative which acts by postsynaptic inhibition of dopamine receptors. Thioridazine has other peripheral and central nervous system effects, producing both alpha adrenergic stimulation and blocking histamine- and serotonin-mediated effects. Thioridazine is indicated for the therapy of acute and chronic psychosis. Thioridazine was approved for use in the United States in 1978 and was formerly a commonly prescribed antipsychotic medication, but in recent years has been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Use of thioridazine is also restricted because of its propensity to cause prolongation of the QTc interval and increased risk of sudden death. Thioridazine is available as tablets of 10, 25, 50 and 100 mg in generic forms and previously under the brand name Mellaril. The usual recommended dose in adults is 50 to 100 mg three times daily, increasing based upon effect and tolerance to a maximum of 800 mg daily. Common side effects include drowsiness, dizziness, headache, blurred vision, dry mouth, constipation, tremor, restlessness, muscle spasms and weight gain. Uncommon but potentially severe adverse events include increased mortality in elderly patients with dementia-associated psychosis, neuroleptic malignant syndrome, tardive dyskinesia, hypotension and falls.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in a high proportion of patients on long term phenothiazine therapy, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Rare instances of clinically apparent acute liver injury have been reported due to thioridazine, with some resemblance to cases of chlorpromazine jaundice. The onset of jaundice occurred within a few weeks to several months of therapy and the pattern of serum enzyme elevations was typically cholestatic, although hepatocellular patterns have also been reported. Immunoallergic manifestations (fever, rash and eosinophilia) were not prominent and autoantibodies were not detected. Some cases were associated with agranulocytosis which is a rare but known complication of the phenothiazines.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which the phenothiazines cause serum aminotransferase elevations is not known. Thioridazine is extensively metabolized by the liver via sulfoxidation and oxidation, and some instances of serum aminotransferase elevations as well as more clinical apparent liver injury may be caused by production of a toxic intermediate of its metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on thioridazine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. The acute clinically apparent liver injury caused by thioridazine is typically self-limited and benign. Instances of chronic cholestasis and vanishing bile duct syndrome have not been reported with thioridazine, but many cases have been attributed to other phenothiazines. Rechallenge with thioridazine usually causes a prompt recurrence of the liver injury and should be avoided. Patients with thioridazine induced liver injury may have cross sensitivity to other phenothiazines, but generally tolerate the atypical antipsychotics.

Drug Class: Antipsychotic Agents

Other Drugs in the Subclass, Phenothiazines: Chlorpromazine, Fluphenazine, Perphenazine, Prochlorperazine, Trifluoperazine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Thioridazine – Generic, Mellaril®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Thioridazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thioridazine | 50-52-2 | C21-H26-N2-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2020

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including chlorpromazine published in 1999; several hundred cases of jaundice due to chlorpromazine have been reported, usually cholestatic, arising after 1-5 weeks, often with fever and eosinophilia, sometimes causing vanishing bile duct syndrome; other phenothiazines have only rarely been linked to a similar form of liver injury, except for prochlorperazine).
Larrey D, Ripault M-P. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of phenothiazines mentions that hundreds of cases of chlorpromazine jaundice have been published, frequency ~0.5-1%; onset in 2-5 weeks, usually acute cholestatic hepatitis with jaundice and pruritus; a prodrome of fever and abdominal pain is common; prolonged course in 7% but often benign; other phenothiazines have been linked to liver injury similar to that of chlorpromazine, “but with a lower frequency”).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Brunold H. (1959). Ther Umsch. (Among 89 patients treated with thioridazine with escalating doses to 800 mg/day, one patient developed jaundice which was not otherwise characterized).
Block SL. (1962). Jaundice following thioridazine administration. Am J Psychiatry. (79 year old woman with dementia developed elevated liver enzymes but without symptoms 9 months after starting thioridazine, resolving rapidly with stopping; jaundice was not mentioned in text of the report).
Winkelmayer R. (1966). Subicterus following the administration of thioridazine and chlordiazepoxide. Del Med J. (35 year old man developed jaundice 24 days after starting thioridazine with slight elevation in “icteric index”, but normal serum bilirubin and aminotransferase levels, a pattern that recurred on chlordiazepoxide but not upon restarting thioridazine).
Reinhart MJ, Benson RM, Kwass SK, Storey WF. (1966). Suggestive evidence of hepatotoxicity concomitant with thioridazine hydrochloride use. JAMA. (3 cases of thioridazine hepatotoxicity; case 1, 53 year old man with rise in ALT [600 U/L], Alk P [~10 fold] and bilirubin [5.2 mg/dL] within days of switching from chlorpromazine to thioridazine and rapid recovery with stopping; case 2, 32 year old woman switched from chlorpromazine to thioridazine because of ALT elevations and 4 months later developed fatigue [bilirubin normal, ALT 320 U/L, Alk P normal], resolving upon stopping; case 3, 17 year old boy had minor ALT elevations [<60 U/L] without Alk P or bilirubin abnormalities on thioridazine).
Walker CO, Combes B. (1966). Biliary cirrhosis induced by chlorpromazine. Gastroenterology. (32 year old woman and 31 year old man developed persistent jaundice [>4 years], cholestasis and liver fibrosis 3 and 4 weeks after starting chlorpromazine; acute cholestatic hepatitis evolving into chronic form with biopsies showing cirrhosis and complications of portal hypertension, most likely due to vanishing bile duct syndrome).
Barancik M, Brandborg LL, Albion MJ. (1967). Thioridazine-induced cholestasis. JAMA. (34 year old man with chronic alcoholism developed jaundice 5 months after being switched from chlorpromazine to thioridazine [bilirubin 6.7 mg/dL, ALT 59 U/L, Alk P 7 Bessey-Lowry U/L], resolving rapidly upon stopping; biopsy showed intrahepatic cholestasis and not alcoholic hepatitis).
Kane FJ, Moore LP. (1971). Hepatotoxicity occurring with thioridazine therapy. South Med J. (13 year old boy developed transient rash after 22 days of thioridazine [bilirubin 2.2 mg/dL, 1.1 direct], which then decreased to normal weeks after stopping; ALT and Alk P levels were not obtained at time of rash, but were normal in follow up).
Ishak KG, Irey NS. (1972). Hepatic injury associated with the phenothiazines. Clinicopathologic and follow-up study of 36 patients. Arch Pathol. (Review of 36 liver biopsies of patients with phenothiazine induced liver injury from Armed Forces Institute of Pathology, 33 due to chlorpromazine and 3 to prochlorperazine hepatotoxicity; mean time to onset 15 days, eosinophilia in 73%, mean peak bilirubin 12.4 mg/dL, Alk P ~8 fold elevated, ALT 146 U/L; 6 [17%] had prolonged course for 10 to 16 months).
Weiden PL, Buckner CD. (1973). Thioridazine toxicity. Agranulocytosis and hepatitis with encephalopathy. JAMA. (54 year old man developed cellulitis and jaundice 7 weeks after starting thioridazine [bilirubin 7.0 mg/dL, AST 68 U/L, Alk P ~5 times ULN], with neutropenia and agranulocytosis on bone marrow biopsy; slow but complete recovery of bone marrow and liver).
Kristensen O. (1975). Tidsskr Nor Laegeforen. (58 year old with a history of chlorpromazine hepatotoxicity developed jaundice 15 months after starting thioridazine and imipramine [bilirubin 3.5 mg/dL, ALT 115 U/L, Alk P 1.5 times ULN], resolving upon stopping both drugs and worsening after short rechallenge with thioridazine).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, 51 were attributed to chlorpromazine [9%, ranking 2nd behind halothane], latency averaged 14 days [range 11-46]; 5 deaths; no mention of other phenothiazines).
Kaplowitz N, Aw TY, Simon FR, Stolz A. (1986). Drug-induced hepatotoxicity. Ann Intern Med. (Review of drug induced hepatotoxicity including phenothiazine jaundice).
Munyon WH, Salo R, Briones DF. (1987). Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl). (In vitro assay for cytotoxicity of 8 neuroleptic drugs found that chlorpromazine was more toxic than haloperidol or loxapine, but similar to other phenothiazines).
Regal RE, Bili JE, Glazer HM. (1987). Phenothiazine-induced cholestatic jaundice. Clinical Pharmacy. (Review of phenothiazine induced liver injury; cross sensitivity is rare “but does exist”).
Urberg M. (1990). Thioridazine-induced non-icteric hepatotoxicity. Report of a case. J Fam Pract. (34 year old man with 100 lb weight gain after 2 years of thioridazine therapy was thought to have “tense ascites” and “hepatic failure”, but liver tests were normal except for ALT of 46 U/L; ascites was not present 1 week later when ultrasound showed “loss of the normal internal echo architecture of the liver”).
Pillans PI. (1996). Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J. (Over 21 year period in New Zealand, there were 943 official reports of liver injury involving 205 drugs; chlorpromazine was in the top 20 drugs implicated accounting for 2.7% of cases; prochlorperazine was cause of 4 cases, but other phenothiazines not mentioned).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were due to chlorpromazine with relative risk of 613: and frequency of 261 per 100,000 person year exposures; no other phenothiazine discussed).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to phenothiazines).
Flanagan RJ. (2008). Fatal toxicity of drugs used in psychiatry. Hum Psychopharmacol. (Deaths from fatal poisonings decreased in England and Wales between 1993-2004, antipsychotic overdose fatalities were higher for phenothiazines than atypicals; deaths/million prescriptions being 29 for chlorpromazine, 15.5 thioridazine, 3.9 trifluoperazine, 13.3 olanzapine, 21 clozapine and 31.3 quetiapine; deaths were due to respiratory depression, not acute liver failure).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents; one each due to quetiapine, nefazodone, fluoxetine and venlafaxine, but none due to phenothiazines).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise review and recommendations on use of antidepressants and antipsychotic medications including phenothiazines; no discussion of hepatotoxicity).
Marwick KF, Taylor M, Walker SW. (2012). Antipsychotics and abnormal liver function tests: systematic review. Clin Neuropharmacol. (Systematic review of the literature found rates of any serum enzyme elevation during antipsychotic therapy to range from 5-78% and "clinically significant' elevations in 0-15%; lists 8 reports of clinically apparent liver injury due thioridazine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to chlorpromazine, the only antipsychotic medication listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.6%] were attributed to antipsychotic agents, including 3 due to quetiapine and 2 to olanzapine, but none to thioridazine or other phenothiazines).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that the phenothiazines commonly cause sedation, postural hypotension and weight gain and often have extrapyramidal effects, but does not mention ALT elevations or hepatotoxicity).
Schreiner NM, Windham S, Barker A. (2017). Atypical neuroleptic malignant syndrome: diagnosis and proposal for an expanded treatment algorithm: a case report. A A Case Rep. (48 year old man with bipolar disorder and NASH underwent liver transplantation and developed confusion, dyskinesia, rigidity, hyperthermia and tachycardia/tachypnea postoperatively having been given lithium, lamotrigine, promethazine and ziprasidone, responding to therapy of neuroleptic malignant syndrome with benzodiazepines and propofol).
Baeza I, de la Serna E, Calvo-Escalona R, Merchán-Naranjo J, Rodríguez-Latorre P, Martínez-Cantarero MC, Andrés P, et al. (2018). One-year prospective study of liver function tests in children and adolescents on second-generation antipsychotics: is there a link with metabolic syndrome?. J Child Adolesc Psychopharmacol. (Among 216 children and adolescents starting atypical antipsychotics, mean weight gain at 6 months was 6.5 kg and mean ALT levels increased by 8.6 U/L, while among 37 taking olanzapine mean weight gain was 10.3 kg and ALT increase 2.6 U/L; increases in ALT associated with development of the metabolic syndrome, mean ALT increasing by 27.8 U/L at 6 months).

## OTHER REFERENCE LINKS

1 Recent References on Thioridazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Thioridazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Thioridazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thioridazine)